# Ergot Alkaloids

## OVERVIEW

### Introduction

Ergot alkaloids are widely used for therapy of acute migraine headaches and include ergotamine and dihydroergotamine, both of which act by causing vasoconstriction of the carotid artery beds. Ergot alkaloids have multiple side effects, but have little effect on the liver and have not been clearly linked to instances of clinically apparent acute liver injury.

### Background

Ergotamine (er got' a meen) and dihydroergotamine are ergot alkaloids that act as vasoconstrictors, probably by stimulating alpha adrenergic receptors particularly in the carotid artery bed. The ergotamines may also have serotoninergic effects which may also be beneficial in migraine. The ergotamines were first reported to alleviate migraine headaches in the 1920s and were introduced into clinical use in the United States in the 1940s. Ergotamine is available in 1 mg tablets in multiple generic forms and under brand names such as Cafergot, Ergomar, Ergostat, Migergot and Wigraine. Various combinations of ergotamine with caffeine (100 mg) and acetaminophen are also available as are rectal suppositories (2 mg with or without caffeine) and sublingual forms (2 mg). The usual recommended dose to abort or treat a vascular headache is 2 mg initially (sublingually or orally) and then 1 to 2 mg every 30 minutes, to a maximum of 6 mg per attack and 10 mg weekly. Dihydroergotamine is available in solution for injection (1 mg/mL) or as a nasal spray (4 mg/mL) in generic forms and under the brand names of DHE 45 and Migranal. The usual recommended dose is 1 mg intramuscularly or intravenously initially, repeated at 1 hour intervals to a total dose of 2 to 3 mg and no more than 6 mg weekly. The nasal spray is given as 0.5 mg to each nostril, repeated every 15 minutes, but to less than 3 mg in 24 hours and 4 mg in one week. The advantage of the nasal and parenteral formulations is the rapid onset of action; the disadvantage is a greater potential for overdose or side effects. Common side effects (ergotism) include nausea, vomiting, light-headedness, numbness and tingling, hypertension, bradycardia, muscle pains and itching. Overdose can cause acute vascular spasm and thrombosis.

### Hepatotoxicity

Neither ergotamine nor dihydroergotamine have been implicated in causing liver enzyme elevations, but they are generally used in limited amounts for short and intermittent periods of time. Ergotamine abuse can lead to arterial or venous spastic episodes, and at least one case of portal and splenic vein thrombosis with resultant noncirrhotic portal hypertension has been reported. Ergotamine overdose can lead to ischemic injury to limbs or viscera, including the liver. However, the ergotamines have not been implicated in cases of clinically apparent liver injury and product labels do not mention ALT elevations or liver injury as potential adverse events.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Ergotamine is extensively metabolized by the liver, but it is given in low doses, and intermediates of its metabolism, even if potentially toxic, are likely conjugated and excreted rapidly and without hepatic injury. The vasospastic actions of ergotamines can cause arterial and venous spasms and potentially thromboses to the hepatic artery or portal systems.

Agents used specifically in management of migraines and vascular headaches include: the ergot alkaloids, ergotamine and dihydroergotamine; and, the serotonin receptor agonists (triptans), including almotriptan, eletriptan, frovatriptan, naratriptan, rizatriptan, sumatriptan and zolmitriptan.

Drug Class: Migraine Headache Agents, Vasoconstrictor Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dihydroergotamine – Generic, Migranal®

Ergotamine – Generic, Cafergot®

DRUG CLASS

Migraine Headache Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ergot+Alkaloids)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Dihydroergotamine | 511-12-6 | C33-H37-N5-O5 | Dihydroergotamine Chemical Structure
Ergotamine | 113-15-5 | C33-H35-N5-O5 | Ergotamine Chemical Structure

## REFERENCES

References updated: 10 February 2018

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999; ergotamine and triptans are not discussed).
Larrey D, Ripault MP. Benzodiazepines. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 455. (Review of hepatotoxicity of neuroleptic drugs does not mention ergotamine or the triptans).
Sanders-Bush E, Mayer SE. 5-Hydroxytryptamine (Serotonin): receptor agonists and antagonists. In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 11th ed. New York: McGraw-Hill, 2006, pp. 297-315. (Textbook of pharmacology and therapeutics).
Fisher PE, Silk DB, Menzies-Gow N, Dingle M. Ergotamine abuse and extra-hepatic portal hypertension. Postgrad Med J 1985; 61: 461-3. (Ergotamine abuse can lead to arteriospasm as well as venous complications; 48 year old woman developed hemiparesis after taking ergotamine 6 mg daily for 3 months which resolved on stopping, but she later presented with esophageal varices, believed to be due to splenic and portal vein thromboses). 4022885
Deviere J, Reuse C, Askenasi R. Ischemic pancreatitis and hepatitis secondary to ergotamine poisoning. J Clin Gastroenterol 1987; 9: 350-2. (29 year old man with suicidal ergotamine overdose presented with hypotension, hypoxia and acidosis and then developed marked ALT [4200 U/L] and amylase [2940 U/L] elevations 2 to 3 days later, resolving rapidly without jaundice; compatible with ischemic injury). 3112214
Block GA, Goldstein J, Polis A, Reines SA, Smith ME. Efficacy and safety of rizatriptan versus standard care during long-term treatment for migraine. Rizatriptan Multicenter Study Groups. Headache 1998; 38: 764-71. (Among 1831 patients treated for up to 12 months and experiencing 46,773 migraine attacks, pain relief was achieved in 2 hours in 80-90% on rizatriptan and 70% on standard care; side effects were similar and there were “no meaningful differences in the incidences of drug related laboratory adverse events”). 11284464
Geraud G, Compagnon A, Rossi A; COZAM Study Group. Zolmitriptan versus a combination of acetylsalicylic acid and metoclopramide in the acute oral treatment of migraine: a double-blind, randomised, three-attack study. Eur Neurol 2002; 47: 88-98. (Among 666 patients with migraine treated with either zolmitriptan or aspirin/metoclopramide, side effects of paresthesias and dizziness were more common with zolmitriptan; no mention of any hepatic side effects). 11844897
Diener HC, Jansen JP, Reches A, Pascual J, Pitei D, Steiner TJ; Eletriptan and Cafergot Comparative Study Group. Efficacy, tolerability and safety of oral eletriptan and ergotamine plus caffeine(Cafergot) in the acute treatment of migraine: a multicentre, randomised, double-blind, placebo-controlled comparison. Eur Neurol 2002; 47: 99-107. (Among 733 patients with migraine treated with either eletriptan or ergotamine/caffeine, side effects were transient and predominately mild or moderate; “No clinically significant laboratory…abnormalities were recorded”). 11844898
Snow V, Weiss K, Wall EM, Mottur-Pilson C; American Academy of Family Physicians; American College of Physicians-American Society of Internal Medicine. Pharmacologic management of acute attacks of migraine and prevention of migraine headache. Ann Intern Med 2002; 137: 840-9. (Guidelines for management of acute migraine and chronic prevention; recommends use of nasal dihydroergotamine or a triptan in patients whose migraines fail to respond to aspirin, acetaminophen or nonsteroidal antiinflammatory agents). 12435222
Loj J, Solomon GD. Migraine prophylaxis: who, why, and how. Cleve Clin J Med 2006; 73: 793-4, 797, 800-1 passim. (Preventive therapy of migraine has limited efficacy and may take 2-3 months to have an effect; the most commonly used agents are beta-blockers, calcium channel blockers, anticonvulsants, tricyclic antidepressants and selective serotonin reuptake inhibitors [SSRIs]). 16970133
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to agents used to treat migraine headaches). 18955056
Whyte CA, Tepper SJ. Adverse effects of medications commonly used in the treatment of migraine. Expert Rev Neurother 2009; 9: 1379-91. (Extensive review of common side effects of medications used to treat migraine; nausea is the most common and dose limiting side effect of ergot alkaloids and can require antiemetics). 19769452
Taylor FR. Acute treatment of migraine headaches. Semin Neurol 2010; 30: 145-53. (Review of diagnosis and acute management of migraine headaches including use of ergot alkaloids). 20352584
Drugs for migraine. Treat Guidel Med Lett 2011; 9: 7-12. (Concise review of current medications used for migraine; no discussion of hepatotoxicity). 21304447
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to drugs for migraine headaches). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to the triptans or other drugs for migraine headaches). 25754159
Drugs for migraine. Med Lett Drugs Ther 2017; 59 (1514): 27-32. Corrected and republished in: JAMA 2017; 317 (21): 2230-1. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/28586886) (Concise review of current medications used for migraine; no discussion of hepatotoxicity). 28170366

## OTHER REFERENCE LINKS

1. Recent References on Ergot Alkaloids: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ergot+Alkaloids)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ergot Alkaloids: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ergot+Alkaloids)